# Ubrogepant

## OVERVIEW

### Introduction

Ubrogepant is an orally available, small molecule inhibitor of the calcitonin gene-related peptide (CGRP) receptor that blocks the action of CGRP, a potent vasodilator believed to play a role in migraine headaches. Ubrogepant is approved for treatment of acute migraine attacks. In clinical trials, urbrogepant was generally well tolerated with only rare instances of transient serum aminotransferase elevations during therapy and with no reported instances of clinically apparent liver injury.

### Background

Ubrogepant (ue broe’ je pant) is a small molecule inhibitor of the receptor for the calcitonin gene- related peptide (CGRP), which is believed to play a role in the pathogenesis of migraine headaches. CGRP is a potent vasodilator and pain-signaling neurotransmitter that is found throughout the central and peripheral nervous system but is particularly common in trigeminal ganglia. Levels of CGRP are elevated during episodes of migraine headache, and administration of the peptide can induce migraines in susceptible patients. For this reason, approaches to inhibition of CGRP signaling were developed as potential therapies for migraine, both as preventive therapies to decrease the rate of migraine as well as for treatment of acute attacks. Several small molecule inhibitors of the CGRP receptor (the “-gepants”) are available for treatment of acute migraine (remigepant, ubrogepant, and zavegepant) and two for prevention of acute attacks (alogepant and remigepant). In several randomized, placebo controlled trials, ubrogepant in oral doses of 50 or 100 mg was found to increase the rate of being free from headache pain 2 hours after dosing (19% to 26% compared to 9% to 11% with placebo). Ubrogepant was approved for treatment of acute migraine headaches in the United States in 2019 and is available in tablets of 50 and 100 mg under the brand name Ubrelvy. The recommended dose is 50 or 100 mg orally as soon as possible after onset of migraine with the option to repeat the dose after 2 hours but not to exceed 200 mg during any 24-hour period. Ubrogepant can be safely given in patients receiving preventive therapy with monoclonal antibodies to CGRP or its receptor. It is not approved for prevention of migraine attacks. Ubrogepant is generally well tolerated with side effects of nausea, dizziness, somnolence, and dry mouth that are generally uncommon (<5%), transient and mild-to-moderate in severity. Hypersensitivity reactions can also occur such as rash, urticaria, and pruritus and can be severe including anaphylaxis, dyspnea, and angioedema which can occur immediately or up to days after administration.

### Hepatotoxicity

In preregistration controlled trials of ubrogepant in several thousand patients, mild-to-moderate serum aminotransferase elevations arose in a small percentage of patients (1% to 2%) and overall rates were not different from those in placebo recipients. In the controlled trials and subsequently with general use, there have been no reports of clinically apparent liver injury attributed to ubrogepant. In contrast, telcagepant, the initial oral CGRP receptor antagonist evaluated as therapy for migraine headaches, was abandoned during development because of several instances of clinically apparent liver injury in recipients that was characterized by marked elevations in serum aminotransferase levels and symptoms of fatigue, nausea and abdominal discomfort arising within 2 to 4 weeks of starting therapy which rapidly resolved with prompt stopping of therapy. Similar episodes have not been reported with ubrogepant.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

Possible mechanisms of liver injury due to ubrogepant are not known. It is metabolized in the liver largely by CYP 3A4 and is susceptible to drug-drug interactions with agents that induced or inhibit this microsomal enzyme. Lower doses should be used in patients receiving CYP 3A4 inhibitors.

### Outcome and Management

Drug Class: Migraine Headache Agents

Other Small Molecule Inhibitors of CGRP Receptors: [underlined: Atogepant], Rimegepant, Zavegepant

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ubrogepant – Ubrelvy®

DRUG CLASS

Migraine Headache Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ubrogepant)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ubrogepant | 1374248-77-7 | C29-H26-F3-N5-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 12 January 2025

Abbreviations: CGRP, calcitonin gene-related peptide.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of CGRP antagonists).
FDA. Clinical Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/211765Orig1s000MedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA multidisciplinary scientific review of the ubrogepant application including specific discussion of hepatic adverse events which consisted mainly of mild-to-moderate ALT or AST elevations which were similar in frequency in ubrogepant vs placebo recipients, and two patients with clinically apparent liver injury had evidence of a preexisting and unrelated diagnosis; cholecystitis and pancreatitis).
Ho TW, Connor KM, Zhang Y, Pearlman E, Koppenhaver J, Fan X, Lines C, et al. Randomized controlled trial of the CGRP receptor antagonist telcagepant for migraine prevention. Neurology 2014; 83: 958-66. (Among 660 patients with migraine enrolled in a controlled trial of telcagepant [140 or 280 mg] vs placebo twice daily for 12 weeks, 13 patients on telcagepant developed ALT elevations above 3 times ULN, generally between weeks 4 and 6 of treatment, and in two instances rising to 33 and 39 times ULN accompanied by symptoms but not jaundice leading to prompt discontinuation and to early termination of the trial because of the risk of significant hepatotoxicity). 25107879
Voss T, Lipton RB, Dodick DW, Dupre N, Ge JY, Bachman R, Assaid C, et al. A phase IIb randomized, double-blind, placebo-controlled trial of ubrogepant for the acute treatment of migraine. Cephalalgia 2016; 36: 887-98. (Among 834 patients treated with ubrogepant [1, 10, 25, 50 or 100 mg] or placebo for an acute attack of migraine, 26% of those receiving 100 mg were headache pain free at 2 hours compared to 9% on placebo, while adverse events more frequent with ubrogepant included low rates of nausea and dizziness and there were no ALT elevations above 3 times ULN). 27269043
Tfelt-Hansen P, Loder E. The Emperor's new gepants: are the effects of the new oral CGRP antagonists clinically meaningful? Headache 2019; 59: 113-7. (Commentary on the relative efficacy of two oral CGRP receptor antagonists, ubrogepant and rimegepant, which show only modest efficacy in acute migraine [therapeutic gain of 5-8%] and only when compared to placebo as compared to well known effective therapies such as aspirin and other nonsteroidal antiinflammatory agents [8-14%] and the triptans [16-32%]). 30451300
Goadsby PJ, Tepper SJ, Watkins PB, Ayele G, Miceli R, Butler M, Severt L, et al. Safety and tolerability of ubrogepant following intermittent, high-frequency dosing: Randomized, placebo-controlled trial in healthy adults. Cephalalgia 2019; 39: 1753-61. (Study of safety of ubrogepant given in intermittent doses [200 mg per day for 2 days] to healthy adults found the overall adverse event rates were the same as with placebo [44% vs 45%], including headache [11% vs 10%] and ALT elevations of 3 times ULN or more [in 5 on placebo and 2 on ubrogepant], which were transient and resolved even with drug continuation and without bilirubin elevations or symptoms). 31537107
Lipton RB, Dodick DW, Ailani J, Lu K, Finnegan M, Szegedi A, Trugman JM. Effect of ubrogepant vs placebo on pain and the most bothersome associated symptom in the acute treatment of migraine: the ACHIEVE II randomized clinical trial. JAMA 2019; 322: 1887-98. (Among 1465 adults with an acute migraine headache, freedom from pain at 2 hours was achieved by 21% and 22% of ubrogepant [25 or 50 mg] vs 14% of placebo recipients, while adverse events of nausea and dizziness were generally mild and uncommon [~ 2%] and ALT or AST elevations of at least 3 times ULN arose in only 4 of 966 [<1%] rimegepant treated patients, all of which were transient and without symptoms or jaundice). 31742631
Dodick DW, Lipton RB, Ailani J, Lu K, Finnegan M, Trugman JM, Szegedi A. Ubrogepant for the treatment of migraine. N Engl J Med 2019; 381: 2230-41. (Among 1672 adults with migraine headache, freedom from pain within 2 hours was achieved by 19% and 21% of ubrogepant recipients [50 or 100 mg] vs 12% of placebo recipients, and adverse events of dry mouth, somnolence and nausea were generally mild and uncommon [less than 5%], while ALT or AST elevations of 3 times ULN or greater arose in 0.4% and 0.6% vs 0.2% of patients on placebo). 31800988
Ailani J, Lipton RB, Hutchinson S, Knievel K, Lu K, Butler M, Yu SY, et al. Long-term safety evaluation of ubrogepant for the acute treatment of migraine: phase 3,randomized, 52-week extension trial. Headache 2020; 60: 141-52. (Among 1230 adults randomized to ubrogepant [50 or 100 mg] or usual care to treat migraine attacks over a 52 week period, elevations in ALT arose in 31% and 32% on ubrogepant vs 31% on usual care and were above 3 times ULN in 1.3% and 2.7% vs 1%, but none of the elevations were associated with jaundice or symptoms). 31913519
Ankrom W, Bondiskey P, Li CC, Palcza J, Liu W, Dockendorf MF, Matthews C, et al. Ubrogepant is not associated with clinically meaningful elevations of alanine aminotransferase in healthy adult males. Clin Transl Sci 2020; 13: 462-72. (In two pharmacokinetic and safety studies conducted in 72 healthy male adults, ubrogepant in single and multiple doses of 40 to 400 mg daily for up to 28 days was well tolerated with no serious adverse events or ALT elevations above 3 times ULN; overall rates of ALT abnormalities were similar to those with placebo). 31899602
Scott LJ. Ubrogepant: First approval. Drugs 2020; 80: 323-8. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of ubrogepant shortly after its approval for use in the US, mentions that ALT or AST elevations above 3 times ULN arose in 1-3% of patients, but none were associated with jaundice and rates were similar between ubrogepant and placebo recipients). 32020557
Lasmiditan (Reyvow) and ubrogepant (Ubrelvy) for acute treatment of migraine. Med Lett Drugs Ther 2020; 62: 35-9. (Concise review of the mechanism of action, clinical efficacy, safety and costs of ubrogepant and lasmiditan as therapy of acute migraine shortly after their approval for this indication in the US, mentions side effects of ubrogepant being nausea and somnolence but does not mention ALT elevations or hepatotoxicity). 32555120
Rimegepant (Nurtec ODT) for acute treatment of migraine. Med Lett Drugs Ther 2020; 62: 70-2. (Concise review of the mechanism of action, pharmacology, clinical efficacy, safety and cost of rimegepant shortly after its approval in the US as therapy of acute migraine in adults, mentions that it “was generally well tolerated in clinical trials; nausea was the most common adverse event [~2%]”). 32555113
Drugs for migraine. Med Lett Drugs Ther 2020; 62: 153-60. (Concise summary of the relative clinical efficacy, safety and costs of drugs to treat acute migraine headache [such as analgesics, opiates, triptans, ergots and oral CGRP receptor antagonists] and to prevent migraines [such as anticonvulsants, beta blockers, antidepressants and the monoclonal antibodies to CGRP and its receptor]). 33434187
Hutchinson S, Dodick DW, Treppendahl C, Bennett NL, Yu SY, Guo H, Trugman JM. Ubrogepant for the acute treatment of migraine: pooled efficacy, safety, and tolerability from the ACHIEVE I and ACHIEVE II phase 3 randomized trials. Neurol Ther 2021; 10: 235-49. (Post hoc analysis of efficacy and safety from two controlled trials in 2240 patients with migraine, found pain-free rates at 2 hours to be 20.5% with ubrogepant vs 13% with placebo, with similar overall rates of adverse events [11.5% vs 11.2%] and no serious adverse events requiring discontinuation). 33608814
Jakate A, Blumenfeld AM, Boinpally R, Butler M, Borbridge L, Contreras-De Lama J, McGeeney D, et al. Pharmacokinetics and safety of ubrogepant when coadministered with calcitonin gene-related peptide-targeted monoclonal antibody migraine preventives in participants with migraine: A randomized phase 1b drug-drug interaction study. Headache 2021; 61: 642-52. (Among 40 patients enrolled in pharmacokinetic studies of ubrogepant with or without concurrent preventive therapy with erenumab or galcanezumab, pharmacokinetic parameters were similar with and without concurrent monoclonal antibodies to CGRP and adverse event rates appeared to be unaffected; there were “no clinically relevant changes in laboratory parameters”). 33818780
Robbins MS. Diagnosis and management of headache: a review. JAMA 2021; 325: 1874-85. (Review of the diagnosis and management of headache including use of calcitonin gene-related peptide antagonists for acute migraine attacks which has uncommon side effects of dry mouth and dizziness; no mention of ALT elevations or hepatotoxicity). 33974014
Woodhead JL, Siler SQ, Howell BA, Watkins PB, Conway C. Comparing the liver safety profiles of 4 next-generation CGRP receptor antagonists to the hepatotoxic CGRP inhibitor telcagepant using quantitative systems toxicology modeling. Toxicol Sci. 2022;188:108-116. (Mechanistic simulation of hepatotoxicity indicated that telcagepant had multiple potential adverse effects on liver function compared to the more recently developed CGRP antagonists, rimegepant, ubrogepant, atogepant, and zavegepant). 35556143
Battini V, Carnovale C, Clementi E, Sessa M. Ubrogepant and rimegepant: signal detection using spontaneous reports of adverse events from the Food and Drug Administration Adverse Event Reporting System. Expert Opin Drug Saf. 2023;22:1105-1112. (Extraction of adverse event reports made to the FDAs Adverse Event Reporting System for ubrogepant [n=2010] and rimegepant [3691] found no excess reports of hepatic reactions). 37293948
Dodick DW, Goadsby PJ, Schwedt TJ, Lipton RB, Liu C, Lu K, Yu SY, et al. Ubrogepant for the treatment of migraine attacks during the prodrome: a phase 3, multicentre, randomised, double-blind, placebo-controlled, crossover trial in the USA. Lancet. 2023;402(10419):2307-2316. (Among 480 adults with episodic migraine treated with ubrogepant [100 mg] or placebo at onset of a prodromal event, subsequent absence of a headache occurred in 46% vs 29% while adverse events were more frequent with drug [17% vs 12%], they being mostly mild-to-moderate nausea [5% vs 3%], fatigue [3% vs 2%], and somnolence [2% vs 1%], with no deaths or serious adverse events [laboratory tests were not done]). 37979595
Drugs for migraine. Med Lett Drugs Ther. 2023;65:89-96. (Concise summary of the relative clinical efficacy, safety, and costs of drugs to treat and to prevent migraine headaches, states that systemic adverse effects are uncommon with use of oral CGRP receptor antagonists, but that nausea and somnolence can occur; no mention of ALT elevations or hepatotoxicity). 37266987
Liang Q, Liao X, Wu H, Huang Y, Liang T, Li H. Real-world study of adverse events associated with gepant use in migraine treatment based on the VigiAccess and U.S. Food and Drug Administration's adverse event reporting system databases. Front Pharmacol. 2024;15:1431562. (Search of two large registry databases on spontaneous reports of adverse events due to -gepants [rimegepant, ubrogepant, and atogepant] identified 23,542 reports, but only 0.09% to 0.27% were liver related, attesting to the lack of severe liver injury due to the currently available oral CGRP receptor antagonists). 39144633
Cao B, Gu S, Shen Z, Zhang Y, Shen Y, Chen H. Evaluating Ubrogepant-related adverse events using the FDA adverse event reporting system. Expert Opin Drug Saf. 2024;23:297-303. (Extraction of data from the FDA’s Adverse Event Reporting System identified 2067 reports attributed to ubrogepant, of which only one was hepatobiliary). 37608560

## OTHER REFERENCE LINKS

1. Recent References on Ubrogepant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ubrogepant+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Ubrogepant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ubrogepant)